# Telotristat

## OVERVIEW

### Introduction

Telotristat is an oral, small molecule inhibitor of tryptophan hydroxylase that is used in the treatment of symptoms of carcinoid syndrome. Telotristat is associated with modest rate of minor serum enzyme elevations during therapy but has not been linked to cases of clinically apparent liver injury.

### Background

Telotristat (tel oh' tri stat) is an oral small molecule inhibitor of tryptophan hydroxylase, an enzyme that is responsible for the rate-limiting step in serotonin (5-hydroxtryptamine) synthesis. Serotonin is a neuroactive signaling molecule that is produced in excess by some neuroendocrine tumors and causes the symptoms of carcinoid syndrome (flushing, diarrhea, abdominal pain and heart valvular complications). Carcinoid syndrome is typically treated with somatostatin analogues that inhibit the growth of neuroendocrine tumors. However, treatment with somatostatin analogues (such as octreotide, lanreotide and pasireotide) does not always control symptoms of carcinoid syndrome, particularly the diarrhea and abdominal discomfort. Telotristat does not decrease the neuroendocrine tumor size or growth but lowers the peripheral synthesis of serotonin which leads to decreased plasma levels. In several small, prelicensure clinical trials, telotristat therapy was associated with a decrease in diarrhea in at least half of treated patients with carcinoid syndrome, with residual diarrheal symptoms despite stable doses of somatostatin analogues. Telotristat was approved for this indication in the United States in 2017 and is available in tablets of 250 mg under the brand name Xermelo. The recommended adult dosage is 250 mg three times daily. Common adverse events include nausea, constipation, flatulence, anorexia, and abdominal pain. Rare, but potentially severe adverse events include severe constipation and depression.

### Hepatotoxicity

In small clinical trials of telotristat in patients with neuroendocrine tumors and symptomatic diarrhea despite stable doses of somatostatin analogues, transient, asymptomatic and mild serum elevations of ALT occurred in 4% to 5% and of GGT in 6% to 9% of treated subjects. Apparent liver injury with jaundice was not observed in the several prelicensure clinical trials and has not been reported in the limited clinical experience with this agent since its approval.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why telotristat might cause serum enzyme elevations is not known but may be a direct toxicity to hepatocytes caused by inhibition of tryptophan hydroxylase or related enzyme activities. Telotristat has little effect on hepatic cytochrome P450 enzymes and has not been implicated in clinically significant drug-drug interactions.

### Outcome and Management

Serum enzyme elevations can occur during telotristat therapy, but they are usually transient and only mild-to-moderate in severity, rarely requiring dose modification. Patients who develop ALT or AST elevations above 5 times the ULN should discontinue telotristat, at least temporarily, until the abnormalities resolve or another cause is identified. There is no known cross sensitivity to hepatic injury among the different small molecule enzyme inhibitors.

Drug Class: Antineoplastic Agents; Gastrointestinal Agents, Antidiarrheal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Telotristat – Xermelo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Telotristat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Telotristat | 1033805-28-5 | C25-H22-Cl-F3-N6-O3 | Telotristat chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 07 April 2019

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of therapies for carcinoid syndrome).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; does not discuss telotristat).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Kulke MH, O'Dorisio T, Phan A, Bergsland E, Law L, Banks P, Freiman J, et al. Telotristat etiprate, a novel serotonin synthesis inhibitor, in patients with carcinoid syndrome and diarrhea not adequately controlled by octreotide. Endocr Relat Cancer 2014; 21: 705-14. (Among 23 patients with carcinoid syndrome and diarrhea despite somatostatin analogue therapy treated with telotristat [150, 250, 350 or 500 mg] vs placebo 3 times daily for 4 weeks, improvement in diarrhea occurred more frequently with telotristat than placebo [75% vs 20%], while ALT elevations were less common [17% vs 40%] and were less than twice baseline in all). 25012985
Pavel M, Hörsch D, Caplin M, Ramage J, Seufferlein T, Valle J, Banks P, et al. Telotristat etiprate for carcinoid syndrome: a single-arm, multicenter trial. J Clin Endocrinol Metab 2015; 100: 1511-9. (Among 15 patients with metastatic neuroendocrine tumors and carcinoid syndrome with diarrhea despite somatostatin analogue therapy treated with telotristat [150 to 500 mg 3 times daily] for 12 weeks, all had some decrease in stool frequency and common side effects were abdominal pain and diarrhea; 1 patient had transient ALT and AST elevations and 1 had GGT elevations, but all were less than twice ULN and none were accompanied by jaundice). 25636046
Telotristat ethyl(Xermelo) for carcinoid syndrome diarrhea. Med Lett Drugs Ther 2017; 59 (1525): 119-20. (Concise review of the mechanism of action, clinical efficacy, safety and costs of telotristat for diarrhea due to carcinoid syndrome shortly after its approval in the US; mentions common adverse events of nausea, headache, depression, flatulence, decreased appetite, edema, fever and GGT elevations, but makes no mention of ALT elevations or hepatotoxicity). 28699933
Kulke MH, Hörsch D, Caplin ME, Anthony LB, Bergsland E, Öberg K, Welin S, et al. Telotristat ethyl, a tryptophan hydroxylase inhibitor for the treatment of carcinoid syndrome. J Clin Oncol 2017; 35: 14-23. (Among 35 patients with carcinoid syndrome and diarrhea despite somatostatin analogue therapy, response rates in reduction of diarrhea were greater with telotristat [250 mg, 44% and 500 mg, 42%] than placebo [20%] given 3 times daily for 12 weeks, and adverse event rates were similar except for nausea [13% and 31% vs 11%] and ALT [4% vs none] and GGT elevations [9% vs none], but no patient developed clinically apparent liver injury or jaundice). 27918724
Markham A. Telotristat ethyl: first global approval. Drugs 2017; 77: 793-8. (Review of the structure, mechanism of action, pharmacology, history of development, clinical efficacy and safety of telotristat shortly after its approval in the US; does not mention ALT elevations or hepatotoxicity). 28382568
Pavel M, Gross DJ, Benavent M, Perros P, Srirajaskanthan R, Warner RRP, Kulke MH, et al. Telotristat ethyl in carcinoid syndrome: safety and efficacy in the TELECAST phase 3 trial. Endocr Relat Cancer 2018; 25: 309-22. (Among 76 patients with carcinoid syndrome and inadequate control of diarrhea on somatostatin analogue therapy treated with telotristat [250 mg or 500 mg] or placebo 3 times daily for 12 weeks, a subset of whom continued telotristat therapy [titrated to 500 mg] for 36 weeks, symptoms of diarrhea decreased more with telotristat therapy than placebo while adverse event rates were similar; ALT elevations occurred in 4.5% and GGT elevations in 6% of those on extended therapy, the enzyme elevations not accompanied by jaundice but led to early discontinuation in 2 patients [3%]). 29330194
Anthony LB, Kulke MH, Caplin ME, Bergsland E, Öberg K, Pavel M, Hörsch D, et al. Long-term safety experience with telotristat ethyl across five clinical studies in patients with carcinoid syndrome. Oncologist 2019 Jan 16. [Epub ahead of print] (Among 239 patients with carcinoid syndrome and diarrhea who were treated with telotristat in 5 clinical trials, adverse events were mostly mild-to-moderate in severity and similar in overall rate in patients receiving placebo; ALT elevations not discussed but there were no hepatic serious adverse events). 30651397

## OTHER REFERENCE LINKS

1. Recent References on Telotristat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Telotristat/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Telotristat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Telotristat)